# Lingzhi, Reishi

## OVERVIEW

### Introduction

Lingzhi (Ganoderma lingzhi), also known as Reishi (usually Ganoderma lucidum), is a large, reddish-brown mushroom with a distinctive fan-like appearance that is used in traditional Chinese medicine for improving health, restoring vitality, and preventing illness. Lingzhi is well tolerated and has not been associated with serum aminotransferase elevations during therapy but has been implicated in rare single instances of acute liver injury, although in most reports other diagnoses were not adequately excluded.

### Background

Lingzhi (Ganoderma lingzhi or lucidum) is a large, reddish-brown mushroom that grows at the base of trees or on tree stumps. Because it is rare in the wild, it is cultivated using logs, sawdust, or wood chips from deciduous trees. Lingzhi has a distinctive bitter taste, and is used in cooking and in making herbal tea. Its major use, however, has been in traditional Chinese medicine where it is considered an immortality herb or “divine” mushroom, capable to improving heath, promoting longevity, preventing illness, and restoring youthful vigor. It has also been used as an adjunct to cancer chemotherapy to enhance antitumor activity. Known as Reishi in Japan and Lingzhi in China, it is now widely used even in Western countries where it is sold as an extract and frequently found in multiingredient dietary supplements that are purported to improve energy, vitality, and mental concentration. Studies in cell culture and animal models suggest that Lingzhi has hypoglycemic, antiinflammatory, antihypertensive, analgesic, antiviral and even antineoplastic activities. However, none of the purported beneficial activities has been demonstrated in adequately sized and properly controlled clinical trials in humans. Compounds found in Lingzhi extracts include polysaccharides, triterpenoids, nucleosides, ergosterols, fatty acids, proteins, peptides and trace elements, but the biologically active component(s) responsible for its purported effects are unknown. Various forms of Lingzhi or Reishi are available either alone as an extract or combined with other herbs and nutritional agents in multiingredient dietary products. The usual dose ranges from 500 mg to 3 grams daily. There is little information about common side effects of Lingzhi extracts in humans. In small short term clinical trials it was usually described as having few or no adverse effects.

### Hepatotoxicity

In multiple small, short term placebo-controlled trials of Lingzhi or Reishi, serum aminotransferase levels did not change during treatment, and there were no reported instances of clinically apparent liver injury or jaundice. Furthermore, Lingzhi and Reishi are not listed in the many reviews of causes of liver injury from herbal and dietary supplements. Nevertheless, there have been a small number of reports from China, Japan, Thailand, and India of clinically apparent liver injury attributed to Lingzhi or Reishi or their extracts. The latency to onset was typically 1 to 2 months, but ranged from a few days to as long as 6 months, presenting with symptoms of fatigue, nausea, abdominal pain, poor appetite, dark urine, and jaundice. In published cases, the liver injury has been hepatocellular and immune allergic reactions (fever, rash) were not common. In some instances, low levels of autoantibodies were found but immunoglobulins were typically normal and liver biopsies were more suggestive of drug induced liver injury than autoimmune hepatitis. Severity in published cases ranged from mild and asymptomatic elevations in serum aminotransferase levels to clinically apparent hepatitis and even severe hepatitis with hepatic failure. Recovery was rapid once the herbal product was stopped and complete within 1 to 3 months with or without corticosteroid therapy. There have been no reports of chronicity. Many of the cases were poorly documented and the attribution to Ganoderma species somewhat weak. In some cases, other common causes of liver injury were not excluded (such as gallstones, acetaminophen overdose, exposure to other herbal products, contaminants of the herbal product). In view of the extensive worldwide use of Ganoderma lucidum and Lingzhi, clinically apparent liver injury from its use must be extremely rare.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism and the ingredient in Reishi and Lingzhi responsible for the liver injury have not been identified. The most characteristic ingredients are polysaccharides and triterpenoids which have been extensively studied in animals and not been linked to liver injury.

### Outcome and Management

Cases of liver injury from Reishi have ranged in severity from minimally symptomatic elevations in serum aminotransferase levels to cases of mild hepatitis resolving rapidly upon stopping to severe hepatitis with symptoms and signs of acute liver failure. Liver injury from Reishi is typically hepatocellular but self-limited in course and chronic injury has not been described. Corticosteroids have been used in some cases but with unclear benefit. Cases of rechallenge have not been reported.

Drug Class: Herbal and Dietary Supplements

Other names: Reishi, Yeongji, Ganoderma lucidum, Ganoderma lingzhi, Ganoderma sichuanense, Divine mushroom.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lingzhi – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at MedlinePlus, NLM (https://medlineplus.gov/druginfo/natural/905.html)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Ganoderic Acid A | 81907-62-2 | C30-H44-O7
Beta-Glucan | 9012-72-0 | C18-H32-O16 | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 05 October 2024

Abbreviations: DILI, drug induced liver injury; HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not Reishi or Lingzhi).
Yuen MF, Ip P, Ng WK, Lai CL. Hepatotoxicity due to a formulation of Ganoderma lucidum (lingzhi). J Hepatol. 2004;41:686-7. (78 year old Chinese woman who had taken Lingzhi for a year and then switched to a powdered formulation developed fatigue and dark urine one month later [bilirubin 15.8 mg/dL, ALT 306, Alk P 388 U/L, INR normal], improved slowly after stopping and had near normal liver tests 5 months later). 15464254
Wachtel-Galor S, Tomlinson B, Benzie IF. Ganoderma lucidum ("Lingzhi"), a Chinese medicinal mushroom: biomarker responses in a controlled human supplementation study. Br J Nutr. 2004;91:263-9. (Among 18 healthy Chinese adults treated with Lingzhi [1.44 gm] or placebo daily for 28 days followed after a 4-6 week washout period with crossover to the alternate treatment, serum markers of antioxidant, vitamin, and lipid status did not change significantly in either group, and therapy was well tolerated with no change in blood counts or serum creatinine, ALT and AST levels). 14756912
Tang W, Gao Y, Chen G, Gao H, Dai X, Ye J, Chan E, Huang M, Zhou S. A randomized, double-blind and placebo-controlled study of a Ganoderma lucidum polysaccharide extract in neurasthenia. J Med Food. 2005;8:53-8. (Among 132 Chinese patients with neurasthenia treated with a polysaccharide extract of Ganoderma lucidum [1800 mg] or placebo capsules 3 times daily for 8 weeks, wellness and fatigue scores improved more with Lingzhi than placebo and therapy was well tolerated and “not associated with hematologic, liver, renal or biochemical toxicity”). 15857210
Wicks SM, Tong R, Wang CZ, O'Connor M, Karrison T, Li S, Moss J, Yuan CS. Safety and tolerability of Ganoderma lucidum in healthy subjects: a double-blind randomized placebo-controlled trial. Am J Chin Med. 2007;35:407-14. (Among 16 volunteers treated with Lingzhi extract [2 gm] or placebo twice daily for 10 days, there were no significant changes in lymphocyte subsets or in ALT, AST, Alk P or bilirubin levels and “no adverse effects of clinical importance”). 17597499
Wanmuang H, Leopairut J, Kositchaiwat C, Wananukul W, Bunyaratvej S. Fatal fulminant hepatitis associated with Ganoderma lucidum (Lingzhi) mushroom powder. J Med Assoc Thai. 2007;90:179-81. (47 year old Thai woman developed jaundice and coma 2 months after switching from boiled Lingzhi slices to a powdered form of 200 mg daily [bilirubin 40.4 mg/dL, ALT 276 U/L, AST 280 U/L, Alk P 132 U/L, INR 4.7], with rapid deterioration and death 6 days later, autopsy showing multilobular necrosis). 17621752
Noguchi M, Kakuma T, Tomiyasu K, Kurita Y, Kukihara H, Konishi F, Kumamoto S, et al. Effect of an extract of Ganoderma lucidum in men with lower urinary tract symptoms: a double-blind, placebo-controlled randomized and dose-ranging study. Asian J Androl. 2008;10:651-8. (Among 50 Chinese male adults with prostate related symptoms treated with Lingzhi [0.6, 6, or 60 mg] or placebo once daily for 8 weeks, symptoms improved slightly with the 6 mg dose but there was no change in prostate size or residual urinary volume, while adverse events were uncommon and there was “no treatment related hematologic, hepatic, or renal toxicity”). 18097503
Noguchi M, Kakuma T, Tomiyasu K, Yamada A, Itoh K, Konishi F, Kumamoto S, Shimizu K, Kondo R, Matsuoka K. Randomized clinical trial of an ethanol extract of Ganoderma lucidum in men with lower urinary tract symptoms. Asian J Androl. 2008;10:777-85. (Among 88 men with lower urinary tract symptoms treated with Ganoderma lucidum [6 mg] or placebo once daily for 12 weeks, there were no changes in urinary symptoms, prostate size, or residual urinary volume and there was “no treatment related hematologic, hepatic or renal toxicity”). 18097505
Chu TT, Benzie IF, Lam CW, Fok BS, Lee KK, Tomlinson B. Study of potential cardioprotective effects of Ganoderma lucidum (Lingzhi): results of a controlled human intervention trial. Br J Nutr. 2012;107:1017-27. (Among 26 patients with cardiovascular risk factors treated with Lingzhi [1.44 gm] or placebo daily for 12 weeks in a double-blind cross-over design, body weight, lipids, blood pressure, and fasting glucose levels did not change, while a slight improvement occurred with insulin levels and there were “no adverse effects in laboratory safety parameters”). 21801467
Soares AA, de Sá-Nakanishi AB, Bracht A, da Costa SM, Koehnlein EA, de Souza CG, Peralta RM. Hepatoprotective effects of mushrooms. Molecules. 2013;18:7609-30. (Review of the hepatoprotective activity of mushrooms, focused largely on in vivo studies of Ganoderma lucidum effects in animal models of carbon tetrachloride or galactosamine hepatotoxicity suggesting that the polysaccharides and triterpenoids are the active principles, and stressing the need for clinical trials in humans with acute liver failure). 23884116
Klupp NL, Kiat H, Bensoussan A, Steiner GZ, Chang DH. A double-blind, randomised, placebo-controlled trial of Ganoderma lucidum for the treatment of cardiovascular risk factors of metabolic syndrome. Sci Rep. 2016;6:29540. (Among 84 Australian adults with diabetes and the metabolic syndrome treated with Ganoderma lucidum alone [3 gm] or with Cordyceps [amount not given], or placebo for 16 weeks, there were no significant changes in body weight, blood pressure, or in fasting blood glucose, HbA1c, and serum lipid levels in the 3 groups; side effects were mild and similar to those in patients on placebo). 27511742
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012; 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbal products identified 185 publications on 60 different herbs, herbal drugs and supplements but does not list or mention Reishi or Lingzhi). 22928722
Navarro VJ, Seeff LB. Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis 2013; 17: 715-35. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal and traditional herbal remedies; no mention of Reishi or Lingzhi). 24099027
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Rleddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60: 1399-408. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products but no case was attributed specifically to Reishi or Lingzhi). 25043597
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107: 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, does not list or discuss Reishi or Lingzhi). 27402097
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al.; Spanish DILI Registry. Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. 2018;16:1495-1502. (Among 856 cases of hepatotoxicity enrolled in the Spanish Drug-Induced Liver Injury Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], no mention of Reishi or Lingzhi). 29307848
Wang GH, Wang LH, Wang C, Qin LH. Spore powder of Ganoderma lucidum for the treatment of Alzheimer disease: A pilot study. Medicine (Baltimore). 2018;97:e0636. (Among 42 Chinese patients with Alzheimer disease treated with spore powder of Lingzhi [1000 mg] or placebo 3 times daily for 6 weeks, there were no differences in changes in neuropsychic symptoms or quality of life measures and no differences in adverse events between the two groups; no mention of ALT or AST levels). 29742702
Wang GH, Li X, Cao WH, Li J, Wang LH. A retrospective study of Ganoderma lucidum spore powder for patients with epilepsy. Medicine (Baltimore). 2018;97:e10941. (Among 18 Chinese patients with epilepsy treated with spore powder of Lingzhi [1000 mg] 3 times daily for 8 weeks, there were no significant changes in seizure frequency or quality of life measures and adverse events were generally mild; no mention of ALT levels or hepatotoxicity). 29879039
Qiu Z, Zhong D, Yang B. Preventive and therapeutic effect of Ganoderma (Lingzhi) on liver injury. Adv Exp Med Biol. 2019;1182:217-242. (Review of studies of the beneficial effects of Lingzhi on liver injury). 31777021
Liu J, Mao JJ, Li SQ, Lin H. Preliminary efficacy and safety of Reishi & Privet Formula on quality of life among non-small cell lung cancer patients undergoing chemotherapy: a randomized placebo-controlled trial. Integr Cancer Ther. 2020;19:1534735420944491. (Among 82 Chinese adults with lung cancer treated with an oral herbal product with Reishi and Privet vs placebo for 6 weeks, there were no significant differences in changes in quality of life scores or in liver related adverse events between the two groups). 32840126
Ahmad R, Riaz M, Khan A, Aljamea A, Algheryafi M, Sewaket D, Alqathama A. Ganoderma lucidum (Reishi) an edible mushroom; a comprehensive and critical review of its nutritional, cosmeceutical, mycochemical, pharmacological, clinical, and toxicological properties. Phytother Res. 2021;35:6030-6062. (Review of the safety and efficacy of Ganoderma lucidum from the published literature concludes that adequately powered clinical studies are needed to verify the biologic activities of Reishi that have been shown in laboratory and animal studies; mentions that hepatotoxicity has been reported in humans with it use [Wanmuang 2007]). 34411377
Kogure T, Koiwai A, Fukushi D, Satoh M, Murakami K, Hirota M, Endo K, et al. Hypereosinophilia with hepatic nodule formation caused by Ganoderma lucidum. Intern Med. 2021;60:3897-3903. (61 year old Japanese man was found to have mildly abnormal liver tests 6 months after resection of colon cancer leading to discontinuation of his adjunctive cancer chemotherapy, whereupon he started a commercial herbal product containing Reishi and developed nausea and fatigue two months later and was found to have multiple hepatic nodules [ALT 66, AST 45 U/L, Alk P 445 U/L, eosinophils 14,310/μL], which on biopsy showed nodules with intense hypereosinophilia; stopping Reishi was followed by resolution of symptoms, abnormal liver tests and disappearance of hepatic nodules). 34911873
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. Herb-induced liver injury: systematic review and meta-analysis. World J Clin Cases. 2021;9:5490-5513. (Systematic review of the literature on HDS induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62] and greater celandine [48]; Lingzhi is not listed or discussed). 34307603
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. 2022;20:e548-e563. (Among 367 cases of hepatotoxicity enrolled in the Latin American Drug-Induced Liver Injury Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3]; Lingzhi is not mentioned). 33434654
Liu C, Song X, Li Y, Ding C, Li X, Dan L, Xu H, Zhang D. A comprehensive review on the chemical composition, pharmacology and clinical applications of Ganoderma. Am J Chin Med. 2023;51:1983-2040. (Review of the chemical analyses, pharmacology and clinical uses of Ganoderma species used in Chinese traditional medicine mentions that Lingzhi has more than 470 natural components including terpenoids, steroids, alkaloids, and phenols, and has antitumor, antiinflammatory, immunomodulatory, hypolipidemic, and hypoglycemic activity, and is used in China to treat malignant tumors and diabetic nephropathy). 37903715
Chen SN, Nan FH, Liu MW, Yang MF, Chang YC, Chen S. Evaluation of immune modulation by β-1,3; 1,6 D-glucan derived from Ganoderma lucidum in healthy adult volunteers, a randomized controlled trial. Foods. 2023;12:659. (Among 157 healthy adult volunteers treated with polysaccharides [β-glucan] derived from Ganoderma lucidum vs placebo for 12 weeks, treated patients had increases in CD3, CD4 and CD8 lymphocytes and NK cells, but caused no serious adverse events or changes in serum ALT or AST levels). 36766186
Khan H, Reyes JVM, Seen T, Irefej B, Ahmad S. Herbal supplement-induced liver injury: a case report. Cureus. 2023;15:e33663. (45 year old woman developed epigastric pain 3 days after starting an herbal tea [bilirubin 1.9 mg/dL, ALT 940 U/L, AST 1465 U/L, Alk P 145 U/L], imaging demonstrating gallstone and biliary sludge but no evidence of biliary obstruction, with rapid improvement after stopping the tea which analysis showed contained multiple herbs including Reishi, Siberian ginseng, and aloe vera). 36819353
Guedikian R, Kim B, Singh G, Alexander R. Ganoderma lingzhi (Reishi Mushroom)-induced acute liver injury in the setting of alcohol use: a case report and review of the literature. Cureus. 2023;15:e45953. (47 year old man developed nausea, headache, and abdominal and leg pain which he treated with alcohol [750 mL daily] and several teaspoons of Reishi mushrooms daily for three days and then presenting to an emergency room with bilirubin 1.5 mg/dL, ALT 990 U/L, Alk P 301 U/L, which resolved rapidly with infusions of N-acetylcysteine and hydration, ALT falling to normal within 2 weeks). 37885515

## OTHER REFERENCE LINKS

1. Recent References on Reishi or Lingzhi: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Reishi%20or%20Lingzhi+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Reishi or Lingzhi: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Reishi%20or%20Lingzhi)